# Streptomycin

## OVERVIEW

### Introduction

Streptomycin is a broad spectrum aminoglycoside antibiotic typically used for treatment of active tuberculosis, always in combination with other antituberculosis agents. Streptomycin is usually used in combination with agents that are known to be hepatotoxic and the role of streptomycin in liver injury has been difficult to assess, but most information suggests that streptomycin is not hepatotoxic.

### Background

Streptomycin (strep" toe mye' sin), an aminoglycoside antibiotic, must be given by parenteral injection and is now considered a second line antituberculosis agent, used largely when toxicity has limited use of first line agents. Like other aminoglycosides, streptomycin is thought to act by binding to bacterial ribosomes and inhibiting protein synthesis. Nevertheless, streptomycin is considered bacteriocidal as well as bacteriostatic. Streptomycin was approved for use in the United States in 1956, but its use for most indications has been replaced by more modern aminoglycoside antibiotics. Streptomycin is available in vials and as lyophilized powder for injection in multiple generic formulations. The typical adult dose is 15 mg/kg per day (1 gram daily) intramuscularly or intravenously, usually for the first 2 to 4 months of antituberculosis therapy only. The dose must be modified based upon renal function. Streptomycin is also effective against several other bacterial infections but its use is generally limited to cases in which conventional, less toxic antibiotics have been ineffective. Common side effects are auditory and renal dysfunction, and routine monitoring with of kidney function and hearing is recommended. Less common but potentially severe adverse reactions include rash, fever, neurologic toxicity, C. difficile associated diarrhea, and acute hypersensitivity reactions.

### Hepatotoxicity

Intravenous and intramuscular therapy with streptomycin has been linked to mild and asymptomatic elevations in serum alkaline phosphatase, but therapy rarely affects aminotransferase levels or bilirubin and changes typically resolve rapidly once streptomycin is stopped. Only isolated case reports of acute liver injury with jaundice have been associated with streptomycin therapy and always in combination with other antituberculosis medications which are more clearly hepatotoxic, such as isoniazid, pyrazinamide and rifampin. Streptomycin and the aminoglycosides are not mentioned in large case series of drug induced liver disease and acute liver failure; thus, hepatic injury from streptomycin must be exceedingly rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Uptake of aminoglycosides into hepatocytes is limited and they are rapidly excreted in the urine; high concentrations are found in mainly in renal tubular cells and hair cells of the inner ear, perhaps explaining why they are more likely to cause nephro- or oto- rather than hepatotoxicity.

[First line medications used in the therapy of tuberculosis in the US include ethambutol, isoniazid, pyrazinamide, rifabutin, rifampin, and rifapentine. Second line medications include streptomycin, capreomycin, cycloserine, ethionamide, fluoroquinolones such as levofloxacin and moxifloxacin, aminoglycosides such as amikacin, and para-aminosalicylic acid (PAS).]

Drug Class: Antituberculosis Agents, Aminoglycosides

Other Drugs in the Class: Bedaquiline, Capreomycin, Cycloserine, Ethambutol, Ethionamide, Isoniazid, Pyrazinamide, Rifabutin, Rifampin, Rifapentine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Streptomycin – Generic

DRUG CLASS

Antituberculosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=streptomycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Streptomycin | 57-92-1 | C21-H39-N7-O12

## ANNOTATED BIBLIOGRAPHY

References updated: 15 September 2021

Zimmerman HJ. Antituberculosis agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 611-21. (Extensive review of hepatotoxicity of antituberculosis medications published in 1999: “Nevertheless, use of streptomycin alone provided data that seem to exonerate it from a hepatotoxic role”).
Verma S, Kaplowitz N. Hepatotoxicity of antituberculosis drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 483-504. (Review of hepatotoxicity of antituberculosis drugs).
Gumbo T. Chemotherapy of tuberculosis, mycobacterium avium complex disease and leprosy. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1067-86. (Textbook of pharmacology and therapeutics).
Gillis S, Texler K. (1960). Unusual reactions to anti-tuberculous chemotherapy. Med J Aust. (36 year old woman treated for tuberculosis with PAS, isoniazid and streptomycin developed rash after 6 days, resolving with stopping PAS but subsequently developed fever and jaundice [bilirubin 5.0 mg/dL], resolving with stopping isoniazid; PAS rechallenge induced rash, but no liver test abnormalities).
Smith JM, Springett VH. (1966). Serum transaminase levels during treatment with isoniazid. Tubercle. (Among 15 patients with drug rash attributed to PAS, 40% had ALT elevations compared to only 1 of 10 with rash attributed to streptomycin).
O'Sullivan DC. (1966). Isoniazid jaundice during the treatment of genitourinary tuberculosis. Tubercle. (44 year old man developed fever and body aches 3 weeks after starting PAS, streptomycin and isoniazid, followed by rash and jaundice [bilirubin 3.0 mg/dL, AST 120 U/L]; restarting isoniazid led to fever, abdominal pain and rise in ALT, restarting PAS led to fever and rash).
Mor F, Leibovici L, Cohen O, Wysenbeek AJ. (1990). Prospective evaluation of liver function tests in patients treated with aminoglycosides. DICP. (Prospective study in 104 patients given gentamicin and 10 given amikacin found no change in ALT, LDH or bilirubin levels, but mild increases in Alk P in 23% of patients; no symptomatic hepatitis).
Lindblad A, Hultcrantz R, Strandvik B. (1994). High doses of aminoglycosides did not produce liver toxicity in patients with cystic fibrosis. J Hepatol. (Five patients with cystic fibrosis underwent yearly liver biopsies; those on intermittent aminoglycoside therapy showed no hepatic abnormalities and liver tests were normal in all).
Nassberger L, DePierre J. (1994). High doses of aminoglycoside antibiotics do not induce liver toxicity because uptake is limited. J Hepatol. (Letter in response to Lindblad [1994] postulating that lack of hepatic injury is due to limited uptake of aminoglycosides in the liver compared to kidney and inner ear).
Ormerod LP, Horsfield N. (1996). Frequency and type of reactions to antituberculosis drugs: observations in routine treatment. Tuber Lung Dis. (Among 1317 patients treated for active tuberculosis, hepatitis was attributed to rifampin in 1.4%, pyrazinamide in 1.2% and isoniazid in 0.3%, but none to ethambutol or streptomycin).
American Thoracic Society. (2003). CDC; Infectious Diseases Society of America. Treatment of tuberculosis. MMWR Recomm Rep. (Recommendations for therapy of tuberculosis including details of drug regimens, side effects, monitoring and optimal approaches to follow up; streptomycin is considered a second line drug for treatment of tuberculosis, requiring parenteral injections and monitoring for renal and ototoxicity, given typically during first 2 months of therapy when drug resistant mycobacterial infection is suspected and now largely replaced by ethambutol).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 1 case was attributed to gentamicin, but none to streptomycin).
Abubakar I, Moore J, Drobniewski F, Kruijshaar M, Brown T, Yates M, Anderson C, et al. (2009). Extensively drug-resistant tuberculosis in the UK: 1995 to 2007. Thorax. (Among 678 extensively drug resistant isolates of tuberculosis reported in the UK between 2005 and 2008, 3.4% were also resistant to capreomycin and 51% to streptomycin).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 25 to antituberculosis agents, including 15 to isoniazid alone [ranking first], 6 to isoniazid combined with other agents, 3 to rifampin and pyrazinamide and 1 to dapsone, but none to streptomycin or other aminoglycosides).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, 181 [58%] were attributed to antituberculosis agents, which accounted for 39 of 54 [72%] fatal cases; streptomycin and aminoglycosides were not specifically mentioned).
Arbex MA, Varella Mde C, Siqueira HR, Mello FA. (2010). Antituberculosis drugs: drug interactions, adverse effects, and use in special situations. Part 2: second line drugs. J Bras Pneumol. (Analysis of adverse effects of second line drugs for tuberculosis; the aminoglycosides [streptomycin, amikacin and kanamycin] are second line agents for tuberculosis and side effects include ototoxicity, neurotoxicity, nephrotoxicity, neuormuscular blockade and hypersensitivity reactions; hepatotoxicity not mentioned).
Caminero JA, Sotgiu G, Zumla A, Migliori GB. (2010). Best drug treatment for multidrug-resistant and extensively drug-resistant tuberculosis. Lancet Infect Dis. (Recommends that treatment of multidrug resistant tuberculosis should always include an injectable drug, the first choice being capreomycin, others being the aminoglycosides streptomycin, kanamycin and amikacin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 53 [6%] implicated drugs for tuberculosis including 48 attributed to isoniazid, but none to streptomycin).
Li X, Liu Y, Zhang E, He Q, Tang YB. (2015). Liver transplantation in antituberculosis drugs-induced fulminant hepatic failure: a case report and review of the literature. Medicine (Baltimore). (39 year old woman developed jaundice 3 months after starting isoniazid, rifampin, and pyrazinamide for latent tuberculosis [bilirubin 9.6 rising to 31.2 mg/dL, ALT 388 U/L, Alk P not given, prothrombin time 74 sec], with progressive hepatic insufficiency leading to liver transplant 4 months later followed by steroid-resistant graft rejection, worsening hepatic function, infections and death from multiorgan failure one year later while being treated with ethambutol, moxifloxacin and streptomycin for tuberculosis).
Garcia-Prats AJ, Schaaf HS, Hesseling AC. (2016). The safety and tolerability of the second-line injectable antituberculosis drugs in children. Expert Opin Drug Saf. (Review of the second line injectable drugs for tuberculosis including capreomycin, discusses ototoxicity, nephrotoxicity, electrolyte disturbances, local injection site reactions, but not hepatotoxicity).
Nataprawira HM, Aliyannissa A, Febrianti SA. (2021). Unusual recurrence of antituberculosis drug-induced hepatotoxicity in children: a case series. Am J Case Rep. (Among 6 children with recurred liver injury on therapy for tuberculosis, in 4 instances the children tolerated streptomycin and ethambutol after having an initial bout, and redeveloped acute injury with reintroduction of isoniazid).
Garcia-Prats AJ, Schaaf HS, Hesseling AC. (2016). The safety and tolerability of the second-line injectable antituberculosis drugs in children. Expert Opin Drug Saf. (Review of the second line injectable drugs for tuberculosis including streptomycin, discusses ototoxicity, nephrotoxicity, electrolyte disturbances, local injection site reactions, but not hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Streptomycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Streptomycin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Streptomycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Streptomycin)